# Apoaequorin

## OVERVIEW

### Introduction

Apoaequorin is a recombinant protein used as a dietary supplement that is purported to improve memory and verbal learning. Apoaequorin has not been associated with serum enzyme elevations during therapy nor with clinically apparent liver injury.

### Background

Apoaequorin is a calcium binding protein found in luminescent jellyfish (Aequorea victoria). When the natural (apo) form of the protein is conjugated with coelenterazine, the resulting protein aequorin has natural bioluminescence when exposed to calcium. For this reason, it has been used as a research molecule to study intracellular physiology and regulation of calcium flux. Recombinant apoaequorin, developed for use in research studies, was subsequently evaluated for its potential to improve memory. The basis for this use of aequorin was its calcium binding characteristics which resembled those of calmodulin, an intracellular protein complex which appears to play a central role in memory. A single trial of oral apoaequorin in patients with memory problems found no overall differences in changes in measures of verbal learning in comparison to placebo, but slightly greater improvements were reported in a subset of patients with normal cognitive test values at baseline. These findings were questioned later because of the lack of evidence that apoaequorin is absorbed orally or can cross the blood-brain barrier. Nevertheless, apoaequorin is marketed as a dietary supplement that supports brain health and helps with aging-related memory loss. It has been used off label in patients with amyotrophic lateral sclerosis and multiple sclerosis. Apoaequorin is available in tablets of 10, 20 and 40 mg under the brand name Prevagen. It has not been approved by the FDA as therapy of memory loss or neurologic illnesses. Side effects were not reported in the few prospective studies that have been published. Adverse events reported to the sponsor have been rare but have included headache, nausea, constipation, edema and hypertension. There have been anecdotal reports of serious adverse events in persons with multiple sclerosis taking apoaequorin including hypotension and depression with suicidal ideation.

### Hepatotoxicity

Apoaequorin is considered generally safe and without major adverse effects. In the human studies that have been published there were no reports of serum enzyme elevations occurring during therapy and no mention of serious adverse events or hepatotoxicity.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Mechanism of Injury

The mechanism by which apoaequorin might cause hepatotoxicity is unclear. Indeed, there is little evidence that apoaequorin is absorbed orally, most proteins being broken down in the stomach and intestines to individual amino acids or short polypeptides. Allergic reactions can occur with proteins taken orally but have not been reported with apoaequorin. The possibility of mislabeling or adulteration with hepatotoxic natural products is always an issue in commercial supplements.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Apoaequorin – Prevagen®

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Apoaequorin | 50934-79-7 (https://pubchem.ncbi.nlm.nih.gov/substance/135325303) | Recombinant Protein | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 11 December 2019

Abbreviations used: HDS, herbal and dietary supplements; ALS, amyotrophic lateral sclerosis.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, germander, chaparral leaf, skullcap and valerian, but not apoaequorin).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; apoaequorin is not discussed).
No authors listed. Apoaequorin. In, Natural medicines: comprehensive database. Available at: https://naturalmedicines.therapeuticresearch.com/databases/food,-herbs-supplements/professional.aspx?productid=1486. (Fact sheet on natural products mentions that apoaequorin is a protein that given orally is purported to improve cognitive function, memory and sleep quality, but that published studies do not adequately support its effectiveness).
Shimomura O. A short story of aequorin. Biol Bull 1995; 189: 1-5. 7654844 (Story of the discovery of aequorin using extracts of the light organ granules of Jellyfish [Aequorinae victoria] and the finding that the luminescence required calcium).
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. 12879994 (Comprehensive review of herbal associated hepatotoxicity; apoaequorin is not listed as causing hepatotoxicity).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. 15390328 (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] attributed to herbal medications, but none to apoaequorin).
Shimomura O. The discovery of aequorin and green fluorescent protein. J Microsc 2005; 217(Pt 1): 1-15. 15655058 (History of the discovery and characterization of aequorin and green fluorescent protein for which Dr. Shimomura was awarded the Nobel Prize in Chemistry in 2008).
Payne AG. Experimental regimen targeting the ependyma slows disease progression in four patients with amyotrophic lateral sclerosis. Med Hypotheses 2009; 72: 548-50. 19200662 (The author hypothesizes that amyotrophic lateral sclerosis is due to production of neurotoxins by cerebrospinal fluid producing brain cells, in support of which he describes 4 patients with ALS who experienced relatively less disease progression when treated with a regimen including a medium chain triglyceride diet, lithium, ubiquinone, noni juice, turmeric extract, glutathione and, in two instances, apoaequorin [20 mg every 2-3 hours]).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012 32: 1543-56. 22928722 (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements, but apoaequorin was not listed).
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. 23121117 (Systematic review of literature on HDS associated liver injury; does not mention apoaequorin).
Moran DL, Marone PA, Bauter MR, Soni MG. Safety assessment of Apoaequorin, a protein preparation: subchronic toxicity study in rats. Food Chem Toxicol 2013; 57: 1-10. 23470325 (Toxicology study of recombinant apoaequorin in rats found no evidence of toxicity even at doses [667 mg/kg daily] far in excess of what is used in humans [20 mg daily]).
ALSUntangled Group. ALSUntangled no. 18: apoaequorin (Prevagen). Amyotroph Lateral Scler Frontotemporal Degener 2013; 14: 78-9. 23030514 (An assessment of the efficacy and safety of apoaequorin by a scientific advisory group for an ALS patient group concluded that there was insufficient data to suggest that it was beneficial in slowing the progression of ALS and that two patients with multiple sclerosis have reported serious adverse events while taking it [hypotension, depression]).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. 25043597 (Among 85 cases of HDS associated liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to an apoaequorin-containing product).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. 27070596 (Listing of published cases of liver injury from HDS products; does not mention or discuss apoaequorin).
Moran DL, Underwood MY, Gabourie TA, Lerner KC. Effects of a supplement containing apoaequorin on verbal learning in older adults in the community. Adv Mind Body Med 2016; 30: 4-11. 26878676 (Among 218 adults with self-reported memory concerns treated with apoaequorin or placebo for 90 days, the number of items correctly recalled was similar in both groups, although small differences were found in a subset of persons with normal recall at baseline).
Spence J, Chintapenta M, Kwon HI, Blaszczyk AT. A brief review of three common supplements used in Alzheimer's disease. Consult Pharm 2017; 32: 412-4. 28701253 (Review of the efficacy and safety apoaequorin, Cerefolin NAC and omega-3-fatty acids as therapy for Alzheimer’s disease; does not mention ALT elevations or hepatotoxicity with any of the 3 and concludes that “meaningful evidence is lacking” for their efficacy).
Brown AC. Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. 27402097 (Description of an online compendium of cases of liver toxicity attributed to HDS products does not mention or discuss apoaequorin).

## OTHER REFERENCE LINKS

1 Recent References on Apoaequorin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/pubmed/?term=(Apoaequorin%2FAE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice%2FCI+OR+bile+duct+diseases%2FCI+OR+liver%2FDE+OR+liver+diseases%2FCI)+AND+(%221900%2F1%2F1%22%5BEDat%5D%3A%222999%2F12%2F31%22%5BEDat%5D))
2 Trials on Apoaequorin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Apoaequorin)